# Orphenadrine

## OVERVIEW

### Introduction

Orphenadrine is a centrally acting muscle relaxant that has been in clinical use for more than 50 years and has not been linked to liver injury or clinically apparent drug induced liver disease.

### Background

Orphenadrine (or fen' a dreen) is a centrally acting, nonopiate analgesic and muscle relaxant. It is a methyl derivative of diphenhydramine (a commonly used antihistamine), but its mechanism of action in causing analgesia and skeletal muscle relaxation is not well defined. Orphenadrine has anticholinergic activity and may act centrally on pain perception. Orphenadrine is currently used for the treatment of acute, painful musculoskeletal conditions and can be given orally or parenterally. Orphenadrine was approved for use as a muscle relaxant in the United States in 1957 and it is still in wide use. Orphenadrine is available in multiple generic forms as standard and extended release tablets of 100 mg. It is also available under commercial names such as Norgesic, Norflex, Deenar, Banflex, Disipal and X-Otag. The recommended dosage is 100 mg twice daily. Orphenadrine is also available in parenteral formulations under the names of Flexoject and Myolin. The parenteral dose recommendation is 60 mg either intravenously or intramuscularly twice daily. The most common side effects are those typical of anticholinergics including drowsiness, dry mouth, diaphoresis, flushing, confusion and visual disturbances. Orphenadrine also has a potential for abuse and fatal overdoses have been reported.

### Hepatotoxicity

Despite its long clinical use, there is no evidence of hepatotoxicity with orphenadrine. Several cases of severe orphenadrine overdose with cardio-respiratory arrest and ischemic hepatic injury have been reported. Conventional doses of orphenadrine appear to be free of hepatic injury.

Likelihood score: E (Unlikely cause of clinically apparent liver injury).

Drug Class: Muscle Relaxants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Orphenadrine – Generic, Norflex®

DRUG CLASS

Autonomic Agents: Muscle Relaxants, Central

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=orphenadrine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Orphenadrine | 83-98-7 | C18-H23-N-O | Orphenadrine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2017

Zimmerman HJ. Muscle spasmolytics. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 544-45. (Expert review of hepatotoxicity published in 1999; discusses dantrolene, chlorzoxazone and baclofen, but not orphenadrine).
Hibbs RE, Zambon AC. Agents acting at the neuromuscular junction and autonomic ganglia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011. p. 255-76. (Textbook of pharmacology and therapeutics).
Blomquist M, Bonnichsen R, Schubert B. Lethal orphenadrine intoxications. A report of five cases. Z Rechtsmed 1971; 68: 111-4. (Case reports of fatalities from suicidal overdose of orphenadrine; most died within hours of ingestion and were found dead or died in status epilepticus with few details and no evidence for hepatic injury). 5555178
Bozza-Marrubini M, Frigerio A, Ghezzi R, Parelli L, Restelli L, Selenati A. Two cases of severe orphenadrine poisoning with atypical features. Acta Pharmacol Toxicol (Copenh) 1977; 41 Suppl 2: 137-52. (Eight cases of overdose. Central nervous system toxicity predominates with seizures and cardio-pulmonary arrest; one case had liver test abnormalities with ALT 236 U/L). 302558
de Mercurio D, Chiarotti M, Giusti GV. Lethal orphenadrine intoxication: report of a case. Z Rechtsmed 1979; 82: 349-53. (Case report of a patient with orphenadrine overdose, found comatose and in cardiac arrest; AST levels were high [1600 U/L]. Autopsy showed evidence of ischemic injury to the liver, most likely due to cardiac arrest rather than direct hepatotoxicity). 433466
Chou R, Peterson K, Helfand M. Comparative efficacy and safety of skeletal muscle relaxants for spasticity and musculoskeletal conditions: a systematic review. J Pain Symptom Manage 2004; 28: 140-75. (Thorough review of the pharmacology, efficacy and side effects of the muscle relaxants). 15276195
Mao YC, Hung DZ, Yang CC, Wang JD. Full recovery from a potentially lethal dose of orphenadrine ingestion using conservative treatment: a case report. Hum Exp Toxicol. 2010; 29: 961-3. (46 year old woman took overdose [4 g] of orphenadrine and within 4 hours developed stupor, coma and seizures, but ultimately recovered despite rhabdomyolysis; no mention of liver injury). 20200196
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.7%] were attributed to a muscle relaxant, but none to orphenadrine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Orphenadrine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Orphenadrine/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/12/01/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Orphenadrine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Orphenadrine)